# Alkylating Agents

## OVERVIEW

Alkylating agents are a class of antineoplastic or anticancer drugs which act by inhibiting the transcription of DNA into RNA and thereby stopping the protein synthesis. Alkylating agents substitute alkyl groups for hydrogen atoms on DNA, resulting in the formation of cross links within the DNA chain and thereby resulting in cytotoxic, mutagenic, and carcinogenic effects. This action occurs in all cells, but alkylating agents have their primary effect on rapidly dividing cells which do not have time for DNA repair. Cancer cells are among the most affected because they are among the most rapidly dividing cells. However, hematopoetic, reproductive, and endothelial cells also divide rapidly which accounts for the common side effects of the alkylating agents: anemia, pancytopenia, amenorrhea, impaired spermatogenesis, intestinal mucosal damage, alopecia, and increased risk of malignancy. The end result of the alkylation process results in the misreading of the DNA code and the inhibition of DNA, RNA, and protein synthesis and the triggering of programmed cell death (apoptosis) in rapidly proliferating tumor cells. The alkylating agents are generally separated into six classes:

(1) The nitrogen mustards [mechlorethamine, cyclophosphamide, ifosfamide, melphalan and

chlorambucil]

2 Ethylenamine and methylenamine derivatives [altretamine, thiotepa]
3 Alkyl sulfonates [busulfan]
4 Nitrosoureas [carmustine, lomustine]
5 Triazenes [dacarbazine, procarbazine, temozolomide]
6 The platinum-containing antineoplastic agents [cisplatin, carboplatin, oxaliplatin], which

are referred to as platinum coordination complexes. These antineoplastic drugs are

usually classified as alkylating agents, although they do not alkylate DNA, but cause

covalent DNA adducts by a different means.

The alkylating agents all have major toxicities, but the predominant toxicities are to the bone marrow and gastrointestinal tract. Most agents have been shown to cause transient serum aminotransferase elevations in a proportion of patients. Several alkylating agents have also been implicated in causing rare cases of idiosyncratic, clinically apparent acute liver injury which is typically cholestatic and best described for temozolomide, cyclophosphamide and chlorambucil, perhaps because these agents are most frequently used and can be given orally over a prolonged period. Importantly, the alkylating agents can also cause sinusoidal obstruction syndrome (veno-occlusive disease) when given in high doses, and nodular regenerative hyperplasia when given for prolonged periods. These latter two hepatic effects are typically dose related and may be due to direct toxicity. The alkylating agents discussed in LiverTox include:

Drug Class: Antineoplastic Agents

- Altretamine
- Bendamustine
- Busulfan
- Carmustine
- Chlorambucil
- Cyclophosphamide
- Dacarbazine
- Ifosfamide
- Lomustine
- Lurbinectedin
- Mechlorethamine
- Melphalan
- Procarbazine
- Streptozocin
- Temozolomide
- Thiotepa
- Trabectedin
- Platinum Coordination Complexes
  - Carboplatin
  - Cisplatin
  - Oxaliplatin

List updated: 27 December 2022